# Citalopram

## OVERVIEW

### Introduction

Citalopram and escitalopram are selective serotonin reuptake inhibitors (SSRIs) and widely used antidepressants. Citalopram is a racemic mixture, whereas escitalopram is its S-enantiomer. Both agents have similar profiles of clinical efficacy and side effects. Both have been associated with rare instances of clinically apparent acute liver injury.

### Background

Citalopram (sye tal' o pram) and escitalopram (es" sye tal' oh pram) are antidepressants that belong to the class of selective serotonin reuptake inhibitors (SSRIs). By blocking the reuptake of serotonin in CNS synaptic clefts, SSRIs increase serotonin levels and serotonin activity which results in antidepressant effects. Citalopram was approved for use in the United States in 1998 and it has become one of the most widely used antidepressant medications, with more than 16 million prescriptions being written yearly. Citalopram is available as tablets of 10, 20 and 40 mg and in an oral solution of 10 mg/5 mL in several generic forms and under the brand name of Celexa. The recommended dosage of citalopram in adults is 20 mg once daily, increasing to 40 mg daily if necessary. Escitalopram was approved for use in the United States in 2002 and is available in tablets of 5, 10, and 20 mg under the brand name Lexapro. The recommended dosage of escitalopram is 10 mg once daily, increasing to 20 mg daily if necessary. Both citalopram and escitalopram are approved for treatment of major depression; escitalopram is also used for generalized anxiety disorder. Side effects of citalopram and escitalopram are similar; common side effects are drowsiness, dyspepsia, nausea, headache, increased sweating and sexual dysfunction. Rare, but potentially severe adverse events include suicidal ideation and behavior, prolongation of the QTc interval, serotonin syndrome, precipitation of acute mania and acute glaucoma.

### Hepatotoxicity

Liver test abnormalities have been reported to occur in less than 1% of patients on citalopram, and elevations are usually modest and rarely require dose modification or discontinuation. Rare instances of acute, clinically apparent episodes of liver injury with marked liver enzyme elevations with or without jaundice have been reported in patients on citalopram and escitalopram. The typical presentation is with fatigue, nausea and abdominal pain 2 to 10 weeks after starting the medication, followed by dark urine and mild jaundice. Both cholestatic and hepatocellular patterns of serum enzyme elevations have been described. Autoimmune (autoantibodies) and immunoallergic features (rash, fever, eosinophilia) are uncommon. Recovery is usually rapid once the agent is stopped.

Likelihood score: C (probable cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which citalopram and escitalopram cause liver injury is not known. Citalopram and escitalopram are extensively metabolized by the liver, mainly via the cytochrome P450 system (CYP 3A4, 2D6 and 2C19) and hepatotoxicity may be mediated by toxic intermediates of their metabolism.

### Outcome and Management

The serum aminotransferase elevations that occur on citalopram therapy are usually self-limited and do not require dose modification or discontinuation of therapy. No instances of acute liver failure or chronic vanishing bile duct syndrome have been attributed to citalopram or escitalopram. Persons with intolerance to citalopram may have similar reactions to other SSRIs and careful monitoring is warranted if other such agents are used.

Drug Class: Antidepressant Agents

Other Drugs in the Subclass, SNRIs/SSRIs: Duloxetine, Fluoxetine, Fluvoxamine, Levomilnacipran, Paroxetine, Sertraline, Venlafaxine, Vilazodone, Vortioxetine

## CASE REPORT

### Case 1. Acute cholestatic liver injury due to citalopram.

[Modified from: Milkiewicz P, Chilton AP, Hubscher SG, Elias E. Antidepressant induced cholestasis: hepatocellular redistribution of multidrug resistant protein (MRP2). Gut 2003; 52: 300-3. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/12524417)]

A 30 year old woman developed jaundice and pruritus 2 months after starting citalopram for depression (10 mg daily for 1 month, followed by 20 mg daily). She had chronic depression and had been treated in the past with fluoxetine for a year without complications, but with inadequate control of her symptoms. She was taking no other medications. She had a history of cholestasis managed with ursodiol during two pregnancies. Blood tests showed a bilirubin of 4.4 mg/dL and prominent elevations in alkaline phosphatase, with minimal increase in aminotransferase levels (Table). Tests for hepatitis A, B and C and for autoimmune liver disease were negative. An abdominal ultrasound showed no evidence of biliary obstruction. A liver biopsy showed intrahepatic cholestasis without bile duct loss, fat or fibrosis. Citalopram was stopped and her jaundice and pruritus resolved over the next two months. When seen 6 months after stopping citalopram, she was asymptomatic of liver disease and serum enzymes were normal.

#### Key Points

Medication: | Citalopram (20 mg daily)
Pattern: | Cholestatic (R=~0.6)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 2 months
Recovery: | 2-3 months
Other medications: | None

#### Laboratory Values

Time After Starting | Time After Stopping | AST (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
8 weeks | 0 | 33 | 637 | 4.4 | Citalopram stopped
12 weeks | 4 weeks | | 610 | 2.5 | Estimated from Figure 1
32 weeks | 24 weeks | 13 | 277 | 0.4
Normal Values | | <35 | <360 | <1.2

#### Comment

The abrupt onset of jaundice and pruritus suggests a cholestatic form of drug induced liver disease, which was confirmed in this case by both the pattern of serum enzyme elevations (an R value of less than 2.0) and liver histology. While usually benign, cholestatic hepatitis from medications can be prolonged. The liver biopsy showing a lack of bile duct loss and the history of cholestasis of pregnancy suggest that interference with bile secretion rather than frank injury to bile ducts was the cause.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Citalopram – Celexa®

Escitalopram – Lexapro®

DRUG CLASS

Antidepressant Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=citalopram+escitalopram)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Citalopram | 59729-33-8 | C20-H21-F-N2-O | Image of Citalopram Chemical Structure
Escitalopram | 128196-01-0 | C20-H21-F-N2-O | Image of Escitalopram Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 12 October 2017

Larrey D, Ripault MP. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 443-62. (Review of hepatotoxicity of antidepressants mentions that clinically apparent liver injury from the SSRIs is rare and citalopram has been implicated in only a few isolated cases).
O'Donnell JM, Shelton RC. Pharmacotherapy of depression and anxiety disorders. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 397-416. (Textbook of pharmacology and therapeutics).
Mourilhe P, Stokes PE. Risks and benefits of selective serotonin reuptake inhibitors in the treatment of depression. Drug Saf 1998; 18: 57-82. (Review of pharmacology, efficacy and safety of SSRIs; no mention of ALT elevations or hepatotoxicity). 9466088
Carvajal García-Pando A, García del Pozo J, Sánchez AS, Velasco MA, Rueda de Castro AM, Lucena MI. Hepatotoxicity associated with the new antidepressants. J Clin Psychiatry 2002; 63: 135-7. (Analysis of cases of hepatotoxicity from antidepressants in Spanish Pharmacovigilance System from 1989-1999, identified 99 cases; among SSRIs, 26 due to fluoxetine, 14 paroxetine, 6 fluvoxamine, 5 sertraline, 3 venlafaxine and 2 citalopram; among tricyclics, 16 clomipramine 7 amitriptyline, 6 imipramine; among miscellaneous, 3 nefazodone and 1 trazodone; but all had similar rates of liver injury ranging from 1 to 3 per 100,000 patient-years of exposure, except for nefazodone at 29 per 100,000 patient-years). 11874214
Gleason OC, Yates WR, Isbell MD, Philipsen MA. An open-label trial of citalopram for major depression in patients with hepatitis C. J Clin Psychiatry 2002; 63: 194-8. (A pilot study in 15 patients given citalopram for depression during interferon therapy of chronic hepatitis C; average serum ALT and AST levels did not change). 11926717
Burke WJ. Escitalopram. Expert Opinion Investig Drugs 2002; 11: 1477-86. (Review of structure, pharmacokinetics, metabolism, efficacy and side effects of escitalopram, the S-enantiomer of citalopram; no mention of hepatotoxicity or ALT elevations on therapy). 12387707
Lucena M, Carvajal A, Andrade R, Velasco A. Antidepressant-induced hepatotoxicity. Expert Opin Drug Saf 2003; 2: 249-62. (Review of hepatotoxicity of antidepressants; antidepressant use has increased markedly between 1992 and 2002, accounting for 5% of cases of hepatotoxicity; SSRIs are less likely to cause injury than tricyclics and MAO inhibitors; range of presentations, typically self-limited and rapid recovery; no hallmarks of hypersensitivity). 12904104
Milkiewicz P, Chilton AP, Hubscher SG, Elias E. Antidepressant induced cholestasis: hepatocellular redistribution of multidrug resistant protein (MRP2). Gut 2003; 52: 300-3. (Two cases of cholestasis due to SSRIs; 30 year old woman with jaundice 8 weeks after starting citalopram [bilirubin 4.4 mg/dL, AST 33, Alk P 637 U/L], resolving within 2 months of stopping [Case 1]; second case was due to paroxetine). 12524417
Spigset O, Hägg S, Bate A. Hepatic injury and pancreatitis during treatment with serotonin reuptake inhibitors: data from the World Health Organization (WHO) database of adverse drug reactions. Int Clin Psychopharmacol 2003; 18:157-61. (Among 27,542 reports of hepatic injury in WHO database, 786 related to SSRIs [3%], including citalopram 42, fluoxetine 222, fluvoxamine 54, paroxetine 191, sertraline 112, nefazodone 91 and venlafaxine 74; only nefazodone has an excess of hepatic reports in relationship to total reports). 12702895
Degner D, Grohmann R, Kropp S, Rüther E, Bender S, Engel RR, Schmidt LG. Severe adverse drug reactions of antidepressants: results of the German multicenter drug surveillance program AMSP. Pharmacopsychiatry 2004; 37 Suppl 1: S39-45. (Analysis of adverse drug reactions reported from 1993-2000 in 35 psychiatric hospitals; 0.7% of SSRI recipients had a severe adverse event which were hepatic in 0.05%). 15052513
Lopez-Torres E, Lucena MI, Seoane J, Verge C, Andrade RJ. Hepatotoxicity related to citalopram. Am J Psychiatry 2004; 161: 923-4. (44 year old man developed fatigue 8 weeks after starting citalopram and clonazepam [bilirubin normal, ALT 1078 U/L, Alk P normal], no rash or fever, resolving within 2 months of stopping citalopram while continuing other agents). 15121663
Solomons K, Gooch S, Wong A. Toxicity with selective serotonin reuptake inhibitors. Am J Psychiatry 2005; 162: 1225. (38 year old with abdominal pain and ALT elevations [378 U/L] without jaundice 9 days after starting fluvoxamine; positive rechallenge and recurrence with citalopram [ALT rising to 379 U/L within 4 days] and positive rechallenge with citalopram again 1 year later). 15930079
Rao N. The clinical pharmacokinetics of escitalopram. Clin Pharmacokinet 2007; 46: 281-90. (Review of pharmacokinetics of escitalopram; few drug-drug interactions despite P450 metabolism) 17375980
del Val Antonana A, Ortiz Polo I, Rosello Sastre E, Moreno-Osset E. Hepatitis toxica por escitalopram [Toxic hepatitis due to escitalopram]. Med Clin (Barc) 2008; 131: 796-9. (49 year old woman developed fatigue, dark urine, jaundice and itching 7 weeks after starting escitalopram [bilirubin 6.1 mg/dL, ALT 2400 U/L, Alk P 116 U/L], fluctuating course and slow recovery within 20 weeks of stopping). 19094887
Neumann H, Csepregi A, Evert M, Malfertheiner P. Drug-induced liver disease related to citalopram. J Clin Psychopharmacol 2008; 28: 254-5. (Onset of fatigue and jaundice after 3 weeks of citalopram with bilirubin 11.0 mg/dL, ALT 851 U/L, Alk P not available, resolution in 3 months). 18344747
Jimmink A, Caminada K, Hunfeld NG, Touw DJ. Clinical toxicology of citalopram after acute intoxication with the sole drug or in combination with other drugs: overview of 26 cases. Ther Drug Monit 2008; 30: 365-71. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/%2018520609) (Summary of 26 cases of citalopram overdose [often with other agents] from the Netherlands between 1997 and 2006; primarily caused tachycardia and decrease in consciousness with no evidence of liver injury).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, 6 cases were attributed to duloxetine, 3 to atomoxetine, 2 to fluoxetine, 2 to bupropion, and 1 to sertraline but none to citalopram or escitalopram). 18955056
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury including 1 to venlafaxine and 1 to fluoxetine, but none to citalopram). 20949552
Molleston JP, Fontana RJ, Lopez MJ, Kleiner DE, Gu J, Chalasani N: Drug-induced Liver Injury Network. Characteristics of idiosyncratic drug-induced liver injury in children: results from the DILIN prospective study. J Pediatr Gastroenterol Nutr 2011; 53: 182-9. (Among 30 children with suspected drug induced liver injury, half [n=15] were due to antimicrobials [minocycline 4, INH 3, azithromycin 3] and the rest largely due to CNS agents and anticonvulsants; one case was attributed to amitriptyline, but no other antidepressant was listed). 21788760
Merino MI, Carrero AA, García JF, Martínez JA. [Citalopram hepatotoxicity]. Med Clin (Barc) 2011; 136: 270-1. Spanish. (83 year old man with multiple medical problems developed marked liver enzyme elevations 4 days after starting citalopram [bilirubin not mentioned, ALT 1155 U/L, Alk P 222 U/L, LDH 2324 U/L, creatinine 2.7 mg/dL], resolving within 5 days of stopping). 20206946
Tomlin A, Reith D, Dovey S, Tilyard M. Methods for retrospective detection of drug safety signals and adverse events in electronic general practice records. Drug Saf 2012; 35: 733-43. (Analysis of a large health care database from New Zealand identified 701 adverse events in 473 of 5612 patients [8.4%] prescribed citalopram).22861670
Kwon H, Lee SH, Kim SE, Lee JH, Jee YK, Kang HR, Park BJ, et al. Spontaneously reported hepatic adverse drug events in Korea: multicenter study. J Korean Med Sci 2012; 27: 268-73. (Summary of 2 years of adverse event reporting in Korea; of 9360 reports, 567 were liver related, but none were attributed to antidepressants). 22379337
Park SH, Ishino R. Liver injury associated with antidepressants. Curr Drug Saf 2013; 8: 207-23. (Review of the commonly used antidepressants and their potential for causing liver injury including summary of 5 cases attributed to citalopram, onset after 4 days to 8 weeks and all resolving without residual injury). 23914755
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, but none were attributed to citalopram or other SSRIs). 24552865
Voican CS, Corruble E, Naveau S, Perlemuter G. Antidepressant-induced liver injury: a review for clinicians. Am J Psychiatry 2014; 171: 404-15. (Review of hepatotoxicity of antidepressants, mentions 4 case reports of injury from citalopram [n=3] and escitopram [n=1] with latency of 4 days to 8 weeks, hepatocellular injury and recovery in all). 24362450
Ferrajolo C, Coloma PM, Verhamme KM, Schuemie MJ, de Bie S, Gini R, Herings R, et al.; EU-ADR consortium. Signal detection of potentially drug-induced acute liver injury in children using a multi-country healthcare database network. Drug Saf 2014; 37: 99-108. (Analyses of large spontaneous reporting adverse event databases from 3 countries between 1995 and 2010 identified 125 drugs with at least one exposed case of unexplained acute liver injury in children, 20 of which had a significant association, one of the 20 being citalopram [3 cases]). 24446276
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/25754159) (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 20 cases [2%] were attributed to antidepressants including 5 due to SSRIs, 3 of which were due to escitalopram).
Friedrich ME, Akimova E, Huf W, Konstantinidis A, Papageorgiou K, Winkler D, Toto S, et al. Drug-induced liver injury during antidepressant treatment: results of AMSP, a drug surveillance program. Int J Neuropsychopharmacol 2016; 19. pii: pyv126. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/26721950) (Among 184,234 psychiatric inpatients from 80 hospitals, 149 cases [0.08%] of drug induced liver injury were reported, with very low rates reported for escitalopram [0.01%: 2 of 18,549] and citalopram [0.02%: 4 of 20,476]).
Gollapudy S, Cronin DC, Pagel PS, Boettcher BT. Serotonin syndrome resulting from acute decompensation of nonalcoholic steatohepatitis cirrhosis in a patient chronically treated with citalopram and tramadol. J Cardiothorac Vasc Anesth 2017; 31: 1385-88. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/27838198) (57 year old woman with cirrhosis developed diarrhea and akathisia thought to be due to hepatic encephalopathy, but worsening with use of linezolid and fluconazole, not improving until citalopram and tramadol were discontinued suggesting acute serotonin syndrome).
Ferrajolo C, Scavone C, Donati M, Bortolami O, Stoppa G, Motola D, Vannacci A, et al.; DILI-IT Study Group. Antidepressant-induced acute liver injury: a case-control study in an Italian inpatient population. Drug Saf 2018; 41: 95-102. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/28770534) (Among 179 cases of hospitalizations for unexplained acute liver injury enrolled in an prospective study between 2010 and 2014, 17 had been exposed to antidepressants including 4 who received citalopram [bilirubin 0.4-0.9 mg/dL, ALT 207- 2938 U/L, Alk P 176-188 U/L], outcomes not provided).

## OTHER REFERENCE LINKS

1. Recent References on Citalopram, Escitalopram: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=citalopram+escitalopram+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Citalopram, Escitalopram: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=citalopram+escitalopram)